# Deferiprone

## OVERVIEW

### Introduction

Deferiprone is an oral iron chelating agent used to treat transfusion related, chronic iron overload. Deferiprone has been linked to a low rate of transient serum aminotransferase elevations during therapy and to rare instances of clinically apparent liver injury.

### Background

Deferiprone (de fer’ i prone) is an orally available iron chelating agent that binds iron with a high affinity and zinc and copper to a lesser extent. In clinical trials in patients with transfusion related iron overload, deferiprone therapy lowered both circulating and tissue (cardiac, liver) iron levels and maintained reduced iron concentrations in patients previously treated long term with subcutaneous infusions of deferoxamine. Deferiprone was approved for use in Europe in 1994, but was not approved in the United States until 2011. Current indications are restricted to patients with transfusion related iron overload due to thalassemic syndromes. Deferiprone is available in tablets of 500 mg under the brand name Ferriprox. The recommended dose is 25 to 33 mg/kg three times daily. Side effects can include nausea, abdominal pain, arthralgias and neutropenia (6%). Severe adverse events include agranulocytosis (1% to 2%) and infections. Weekly monitoring of white blood cell counts is recommended.

### Hepatotoxicity

In large clinical trials, elevations in serum aminotransferase levels occurred in 7.5% of patients treated with deferiprone and led to drug discontinuation in ~1%. In many situations, it was unclear whether the ALT elevations were due to deferiprone therapy as opposed to spontaneous worsening of an underlying chronic hepatitis B or C, which is common in patients with transfusion related iron overload. Furthermore, there have been very few reports of clinically apparent liver injury attributed to deferiprone therapy and the clinical features of hepatic injury from deferiprone (latency to onset, pattern of serum enzyme elevations, clinical symptoms and laboratory findings, subsequent course) have not been defined.

Iron overload itself can cause liver injury and result in significant fibrosis and even cirrhosis. By decreasing hepatic iron stores, deferiprone and other iron chelators should improve liver disease and prevent progression of fibrosis. In a controversial open label study of deferiprone therapy for up to 4 years in 19 patients with thalassemia and iron overload, progression of fibrosis was found in 5 of 12 subjects who underwent repeat liver biopsy after an average of 4 years, compared to none of 12 subjects who were separately followed while being treated with deferoxamine. Several subsequent studies, however, failed to show fibrosis progression in subjects with thalassemia and iron overload treated with deferiprone, particularly among those without concurrent hepatitis C.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of injury accounting for serum enzyme elevations during deferiprone therapy is not known. Deferiprone is metabolized in the liver largely by glucuronidation to a more water soluble complex with subsequent urinary excretion.

### Outcome and Management

Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to dose reduction or temporary cessation. Deferiprone has not been implicated in cases of severe hepatitis, acute liver failure, chronic hepatitis or vanishing bile duct syndrome. Despite this, the product label recommends monitoring of serum ALT levels during treatment and interuption if levels are persistently elevated. There does not appear to be cross reactivity in risk for hepatic injury between deferiprone and other iron chelators including deferoxamine and deferasirox.

Drug Class: Hematological Agents; Chelating Agents, Iron Chelators

Other Drugs in the Subclass, Iron Chelators: Deferasirox, Deferoxamine

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Deferiprone – Ferriprox®

DRUG CLASS

Hematological Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Deferiprone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Deferiprone | 30652-11-0 | C7-H9-N-O2 | Deferiprone structure

## ANNOTATED BIBLIOGRAPHY

References updated: 27 December 2017

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of deferiprone).
Byrns MC, Penning TM. Treatment of metal exposure. Environmental toxicology: carcinogens and heavy metals. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1872-6. (Textbook of pharmacology and therapeutics).
Olivieri NF, Brittenham GM, Matsui D, Berkovitch M, Blendis LM, Cameron RG, McClelland RA, et al. Iron-chelation therapy with oral deferiprone in patients with thalassemia major. N Engl J Med 1995; 332: 918-22. (Among 21 patients with beta thalassemia and iron overload treated with oral deferiprone for an average of 3 years, serum ferritin and liver iron concentrations decreased; ALT levels decreased in most patients, but fluctuated significantly in one patient who was positive for anti-HCV). 7877649
Olivieri NF, Brittenham GM, McLaren CE, Templeton DM, Cameron RG, McClelland RA, Burt AD, et al. Long-term safety and effectiveness of iron-chelation therapy with deferiprone for thalassemia major. N Engl J Med 1998; 339: 417-23. (Among 19 patients with thalassemia major and iron overload who were treated with deferiprone for an average of 4.6 years, repeat liver biopsies showed progression of fibrosis in 5 of 14 patients with available liver histology; in contrast, no progression of histologic fibrosis was found in 12 separately studied subjects who had been treated with deferoxamine infusions). 9700174
Cohen AR, Galanello R, Piga A, Dipalma A, Vullo C, Tricta F. Safety profile of the oral iron chelator deferiprone: a multicentre study. Br J Haematol 2000; 108: 305-12. (Among 187 patients with beta thalassemia and iron overload treated with deferiprone for at least one year, neutropenia arose at a rate of 5.4 and agranulocytosis at 0.6 per 100 patient years; ALT elevations [ ≥2 times ULN] were frequent even before therapy [23%] and 85% of patients had anti-HCV). 10691860
Ceci A, Baiardi P, Felisi M, Cappellini MD, Carnelli V, De Sanctis V, Galanello R, et al. The safety and effectiveness of deferiprone in a large-scale, 3-year study in Italian patients. Br J Haematol 2002; 118: 330-6. (Among 532 patients with thalassemia enrolled into a program to distribute deferiprone, neutropenia occurred at a rate of 2.1 and agranulocytosis at 0.4 per 100 patient years after 5-13 months of therapy and ALT elevations occurred in 15 patients [2.8%], 5 of whom discontinued therapy for this reason). 12100170
Cohen AR, Galanello R, Piga A, De Sanctis V, Tricta F. Safety and effectiveness of long-term therapy with the oral iron chelator deferiprone. Blood 2003; 102: 1583-7. (Among 187 patients with thalassemia and iron overload treated with deferiprone for up to 4 years, agranulocytosis occurred in 0.2 and neutropenia in 2.8 per 100 patient years; ALT fluctuated with no consistent change or pattern, 1 patient stopped therapy for ALT elevations and 1 for hepatitis, but no patient developed evidence of end stage liver disease). 12763939
Wanless IR, Sweeney G, Dhillon AP, Guido M, Piga A, Galanello R, Gamberini MR, et al. Lack of progressive hepatic fibrosis during long-term therapy with deferiprone in subjects with transfusion-dependent beta-thalassemia. Blood 2002; 100: 1566-9. (Independent reading of liver biopsies by 3 pathologists from 56 patients with iron overload taken before and after deferiprone therapy scored fibrosis as decreasing slightly in 11 without hepatitis C [Ishak fibrosis scores decreasing from 1.12 to 0.97] and rising slightly among 45 with hepatitis C [1.91 and 2.04], neither change being statistically significant). 12176871
Wu SF, Peng CT, Wu KH, Tsai CH. Liver fibrosis and iron levels during long-term deferiprone treatment of thalassemia major patients. Hemoglobin 2006; 30: 215-8. (Among 17 patients with thalassemia and iron overload treated with deferiprone for an average of 3.3 years, overall fibrosis scores did not change, but they increased in 2 patients one of whom had hepatitis C). 16798646
Ha SY, Chik KW, Ling SC, Lee AC, Luk CW, Lam CW, Ng IO, et al. A randomized controlled study evaluating the safety and efficacy of deferiprone treatment in thalassemia major patients from Hong Kong. Hemoglobin 2006; 30: 263-74. (Among 26 patients treated with deferiprone with or without deferoxamine, 6 [23%] had fluctuating ALT elevations which resolved with stopping deferiprone, but did not always recur with restarting; liver biopsies in 18 patients showed slightly increased fibrosis in 4, but decreased or resolution of fibrosis in an equal number). 16798652
Jamuar SS, Lai AH. Safety and efficacy of iron chelation therapy with deferiprone in patients with transfusion-dependent thalassemia. Ther Adv Hematol 2012; 3: 299-307. (Review of safety and efficacy of deferiprone mentions that "transaminitis" occurs in up to 60% of treated subjects, but is nonprogressive and usually resolves spontaneously without routine need for discontinuation). 23616917
Viprakasit V, Nuchprayoon I, Chuansumrit A, Torcharus K, Pongtanakul B, Laothamatas J, Srichairatanakool S, et al. Deferiprone (GPO-L-ONE(®)) monotherapy reduces iron overload in transfusion-dependent thalassemias: 1-year results from a multicenter prospective, single arm, open label, dose escalating phase III pediatric study (GPO-L-ONE; A001) from Thailand. Am J Hematol 2013; 88: 251-60. (Among 73 children with severe thalassemia major treated with deferiprone for at least one year, serum ferritin levels did not change overall, but did decrease in those with initially very high levels; elevations in ALT occurred in 16% which led to stopping therapy in 6 patients). 23460233
Xia S, Zhang W, Huang L, Jiang H. Comparative efficacy and safety of deferoxamine, deferiprone and deferasirox on severe thalassemia: a meta-analysis of 16 randomized controlled trials. PLoS One 2013; 8: e82662. (Systematic review and metaanalysis of 16 publications comparing iron chelating agents found differences in myocardial content, but not "live iron" concentrations with different therapies, and that the combination of deferoxamine and deferiprone had "higher risk" than deferoxamine). 24376563
Huang WF, Chou HC, Tsai YW, Hsiao FY. Safety of deferasirox: a retrospective cohort study on the risks of gastrointestinal, liver and renal events. Pharmacoepidemiol Drug Saf 2014; 23: 1176-82. (Retrospective analysis of a Taiwanese health database found that first time users of deferasirox had higher crude rates of acute liver necrosis than those on deferoxamine [2 of 133 vs 21 of 3507 patients: 0.26 vs 0.05 per 10,000 patient days], yet the differences in rates were not statistically significant). 24946110
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were chelating agents such as deferoxamine, deferiprone or deferasirox). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no case was attributed to deferoxamine or deferiprone but 1 was due to deferasirox, a 54 year old woman with hemochromatosis who developed ALT elevations [rising from 25 to 305 U/L] without symptoms or jaundice a month after starting deferasirox that resolved rapidly with stopping and recurred upon restarting). 25754159
Calvaruso G, Vitrano A, Di Maggio R, Ballas S, Steinberg MH, Rigano P, Sacco M, et al.; The Investigators of the Multicenter Randomized Clinical Trial of Deferiprone versus Deferoxamine in Sickle-Cell-Disease. Deferiprone versus deferoxamine in sickle cell disease: results from a 5-year long-term Italian multi-center randomized clinical trial. Blood Cells Mol Dis 2014; 53: 265-71. (Among 60 patients with sickle cell anemia and iron overload treated with deferiprone or deferoxamine for up to 5 years, serum ferritin levels decreased in both groups to a similar extent, and "liver damage" [increase twice the normal value] occurred in 10% of deferiprone, but none of deferoxamine treated subjects). 24814618
Botzenhardt S, Li N, Chan EW, Sing CW, Wong IC, Neubert A. Safety profiles of iron chelators in young patients with haemoglobinopathies. Eur J Haematol 2017; 98: 198-217. (Review of literature on safety of iron chelators in young patients reported "increased liver enzymes" in 4% of subjects on deferoxamine, 6% on deferiprone and 20% on deferasirox; no mention of clinically apparent liver injury). 27893170
Parakh N, Chandra J, Sharma S, Dhingra B, Jain R, Mahto D. Efficacy and safety of combined oral chelation with deferiprone and deferasirox in children with β-thalassemia major: an experience from North India. J Pediatr Hematol Oncol 2017; 39: 209-13. (Among 33 children with beta-thalassemia and iron overload being treated with deferiprone or deferasirox who were then placed on both agents, 27% developed elevations of ALT or AST above twice ULN, which were usually transient and self-limited or responded to dose reduction of deferasirox). 28221264
Botzenhardt S, Felisi M, Bonifazi D, Del Vecchio GC, Putti MC, Kattamis A, Ceci A, et al.; DEEP Consortium. Long-term safety of deferiprone treatment in children from the Mediterranean region with beta-thalassaemia major: the DEEP-3 multi-centre observational safety study. Haematologica 2018; 103: e1-e4. (Among 297 children with beta-thalassemia observed following initiation of deferiprone therapy for an average of 2.5 years, 32 [10%] developed serum aminotransferase elevations which led to discontinuation in 21 [6.7%]; no mention of clinically apparent liver injury or acute liver failure). 29079595
Elalfy MS, Adly A, Awad H, Tarif Salam M, Berdoukas V, Tricta F. Safety and efficacy of early start of iron chelation therapy with deferiprone in young children newly diagnosed with transfusion-dependent thalassemia: A randomized controlled trial. Am J Hematol 2017 Nov 9. [Epub ahead of print] (Among 64 young children with thalassemia randomized to early treatment with deferiprone or no chelation, there were no unexpected averse events and liver enzymes that were elevated before treatment fell into the normal range). 29119631

## OTHER REFERENCE LINKS

1. Recent References on Deferiprone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Deferiprone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Deferiprone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Deferiprone)